# Phenelzine

## OVERVIEW

### Introduction

Phenelzine is a monoamine oxidase inhibitor (MAO inhibitor) used in therapy of moderate-to-severe depression. Phenelzine therapy is associated with rare instances of clinically apparent acute liver injury.

### Background

Phenelzine (fen' el zeen) is a hydrazine derivative and antidepressant that acts through inhibition of monoamine oxidase, an enzyme that inactivates several neurotransmitter amines such as norepinephrine and serotonin. By inhibition of catabolism of serotonin and norepinephrine, phenelzine increases brain levels of these neurotransmitters which probably underlie its antidepressant effects. Phenelzine was approved for use as therapy of depression in the United States in 1961, but it is now rarely used because of the availability of more potent and better tolerated antidepressants such as the tricyclic antidepressants and the selective serotonin reuptake inhibitors. Phenelzine is available in generic forms and under the brand name of Nardil as tablets of 15 mg. The usual adult dose of phenelzine is 15 to 30 mg three times daily. Common side effects include drowsiness, dizziness, headache, insomnia, tremor, dry mouth, nausea, increased appetite, weight gain and sexual dysfunction. Phenelzine interacts with many medications as well as many foods and beverages, and patients require careful monitoring and education. Uncommon but potentially serious adverse events include hypertensive crises from dietary tyramine, serotonin syndrome, withdrawal mania and hypersensitivity reactions.

### Hepatotoxicity

Phenelzine, like most monoamine oxidase inhibitors, can cause transient serum aminotransferase elevations in a proportion of patients. These elevations are usually mild, asymptomatic and self-limited and do not require dose modification. Phenelzine has also been associated with cases of acute, clinically apparent liver injury. The liver injury associated with MAO inhibitors typically arises 1 to 3 months after starting therapy and presents with a hepatocellular pattern of serum enzyme elevations. The acute hepatitis-like syndrome can be severe and even fatal. Cholestatic liver injury due to phenelzine has also been described (Case 1). Immunoallergic features (rash, fever, eosinophilia) are uncommon as is autoantibody formation. While few cases of phenelzine liver injury have been published, instances of severe jaundice and fatalities due to liver injury have been reported to the FDA and the sponsor.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which phenelzine causes serum aminotransferase elevation is not known. It undergoes extensive hepatic metabolism, and a possible cause of liver injury is production of an intermediate of metabolism that is directly toxic to hepatocytes or that induces a hypersensitivity response.

### Outcome and Management

The serum aminotransferase elevations that occur on phenelzine therapy are usually self-limited and mild and do not require dose modification or discontinuation of therapy. The clinically apparent, acute liver injury caused by phenelzine is typically self-limited, but progressive and fatal instances of acute hepatitis have been reported. Rechallenge usually causes a prompt recurrence of the liver injury and should be avoided. Patients with phenelzine induced liver injury may have cross sensitivity to other monoamine oxidase inhibitors, but should be able to tolerate tricyclic antidepressants or selective serotonin reuptake inhibitors.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, MAO Inhibitors: Isocarboxazid, Tranylcypromine

## CASE REPORT

### Case 1. Severe and prolonged liver injury due to phenelzine.(1)

A 59 year old man developed fatigue and itching followed by jaundice 2 months after starting phenelzine and shortly after a dose escalation from 45 to 60 mg daily. He had no history of liver disease or exposure to viral hepatitis and drank alcohol only moderately. Other medications included colchicine, probenecid, chlordiazepoxide and flurazepam. Physical examination showed jaundice without rash or fever or signs of chronic liver disease. Serum bilirubin was 9.8 mg/dL and serum enzymes were raised (Table). There was no eosinophilia and tests for hepatitis B and autoantibodies were negative. Phenelzine was stopped, but liver tests did not improve rapidly. A liver biopsy showed areas of lobular collapse, inflammation and intrahepatic cholestasis and unusual, amorphous and unidentified extracellular deposits. He was treated with prednisone (15 mg daily) and azathioprine (50 mg daily) with a clinical and biochemical response, but serum enzymes remained mildly abnormal for somewhat more than a year before becoming persistently normal. Follow up liver biopsy showed resolution of the acute injury, but presence of fibrosis and partial cirrhosis.

#### Key Points

Medication: | Phenelzine (60 mg daily)
Pattern: | Cholestatic (R=0.6)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 2 months
Recovery: | 18 months
Other medications: | Colchicine, probenecid, chlordiazepoxide, flurazepam

#### Laboratory Values

Time After Starting | Months After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 20 | 80 | 1.0
Phenelzine given for two months
2 months | 0 | 148 | 520 | 9.8 | Liver biopsy
3 months | 1 month | 55 | 300 | 1.9
4 months | 2 months | 100 | 680 | 1.2 | Liver biopsy
5 months | 3 months | 95 | 425 | 1.0
6 months | 4 months | 65 | 300
7 months | 5 months | 55 | 220
10 months | 8 months | 45 | 130 | 0.8
1 year | 1 year | 30 | 170 | | Liver biopsy
1.8 years | 1.5 years | 45 | 85 | 0.5
Normal Values | | <40 | <85 | <1.2

Dates and values estimated from Figure 1.

#### Comment

The monoamine oxidase (MAO) inhibitors are no longer commonly used and most reported cases of hepatotoxicity were published before 1990. The described case is unusual because of the prolonged injury and development of cirrhosis, despite prompt discontinuation of the medication. Actually, clinical and histologic long term follow up is rarely available in cases of acute drug induced liver disease, and some degree of residual fibrosis and even cirrhosis may occur particularly if the acute episode is severe and prolonged.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Phenelzine – Generic, Nardil®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=phenelzine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Phenelzine | 51-71-8 | C8-H12-N2

## CITED REFERENCE

1 Bonkovsky HL, Blanchette PL, Schned AR. (1986). Severe liver injury due to phenelzine with unique hepatic deposition of extracellular material. Am J Med.

## ANNOTATED BIBLIOGRAPHY

References updated: 08 April 2020

Abbreviations: MAO, monoamine oxidase; SSRI, selective serotonin reuptake inhibitor; SNRI, serotonin and norepinephrine reuptake inhibitor.

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999; hepatic injury caused by MAO inhibitors is similar to that of isoniazid with which they share structural similarity as hydrazines; the pattern of injury is typically hepatocellular and arises within 1-6 months of starting therapy; cases of fatal acute liver failure have been described, most commonly with iproniazid and less commonly with phenelzine and isocarboxazid, and least commonly with the nonhydrazide MAO inhibitor, tranylcypromine).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants mentions that among MAO inhibitors iproniazid most commonly caused liver injury and phenelzine rarely).
O'Donnell JM, Bies RR, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-77. (Textbook of pharmacology and therapeutics).
Rosenblum LE, Korn RJ, Zimmerman HJ. (1960). Hepatocellular jaundice as a complication of iproniazid therapy. Arch Intern Med. (Classic paper on iproniazid hepatotoxicity; review of 90 patients; more common in women, ages 25-75 years, onset in 1-4 months [~95%], usually hepatocellular pattern similar to viral hepatitis, 22% mortality and demonstration that this is higher than in acute viral hepatitis).
Holdsworth CD, Atkinson M, Goldie W. (1961). Hepatitis caused by the newer amine-oxidase-inhibiting drugs. Lancet. (Four cases of severe liver injury with cross sensitivity to several MAO inhibitors including iproniazid, pheniprazine and nialamide; case 4 was a 56 year old woman who developed jaundice and itching 5 months after starting phenelzine [bilirubin 2.8 mg/dL, ALT 150 U/L, Alk P 3 times ULN], resolving rapidly upon stopping).
Crisp AH, Hays P, Carter A. (1961). Three amine-oxidase inhibitor drugs in the treatment of depression. Relative value and toxic effects. Lancet. (Prospective study of liver test abnormalities during courses of iproniazid [n=17], nialamide [18] and peniprazine [20] with minor increases noted; no data on frequency of levels above normal).
Cook GC, Sherlock S. (1965). Jaundice and its relation to therapeutic agents. Lancet. (Summary of cases of drug induced liver disease seen at Royal Free Hospital from 1959-65; 11 cases of acute liver failure due to drugs including iproniazid [n=3], phenelzine [2], phenoxypropazine [2], prochlorperazine [1] and halogenated anesthetics [3]; 20 cases of cholestatic hepatitis due to drugs, 18 due to chlorpromazine, 1 perphenazine and 1 nitrofurantoin).
Daneshmend TK, Scott GL, Bradfield JW. (1979). Angiosarcoma of liver associated with phenelzine. Br Med J. (64 year old woman who had been on phenelzine for 6 years developed angiosarcoma; phenelzine reported to cause angiosarcomas in mice).
Bonkovsky HL, Blanchette PL, Schned AR. (1986). Severe liver injury due to phenelzine with unique hepatic deposition of extracellular material. Am J Med. (59 year old man developed jaundice 2.5 months after starting phenelzine [bilirubin 9.8 mg/dL, AST 148 U/L, Alk P 520 U/L], prolonged course requiring corticosteroids, ultimate resolution but cirrhosis present on biopsy: Case 1).
Zimmerman HJ, Ishak KG. (1987). The hepatic injury of monoamine oxidase inhibitors. J Clin Psychopharmacol. (Editorial on the hepatotoxicity of MAO inhibitors which occurs in ~1% of patients taking iproniazid, but in a lesser proportion with other hydrazine derivatives such as phenelzine and isocarboxazid; the injury is idiosyncratic, usually hepatocellular and has a high [>10%] fatality rate).
Steingart AB, Cotterchio M. (1995). Do antidepressants cause, promote, or inhibit cancers?. J Clin Epidemiol. (Conflicting data from animal studies and epidemiological surveys have provided little evidence of a link between antidepressant use and breast, liver or other cancer after control for confounding variables).
Gómez-Gil E, Salmerón JM, Mas A. (1996). Phenelzine-induced fulminant hepatic failure. Ann Intern Med. (Reports two cases of acute liver failure due to phenelzine, but no specific results given).
Lucena MI, Carvajal A, Andrade RJ, Velasco A. (2003). Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; MAO inhibitors were first antidepressants developed; iproniazid caused a severe hepatitis and was withdrawn; phenelzine is still in use but has been associated with severe cases of hepatitis and development of cirrhosis).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to MAO inhibitors).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, 3 of which were linked to antidepressants: one each for nefazodone, fluoxetine and venlafaxine, but none to phenelzine or MAO inhibitors).
Sedky K, Nazir R, Joshi A, Kaur G, Lippmann S. (2012). Which psychotropic medications induce hepatotoxicity?. Gen Hosp Psychiatry. (Review of the hepatotoxicity of psychotropic drugs in common use, mentions that phenelzine can cause severe acute or chronic liver injury).
Park SH, Ishino R. (2013). Liver injury associated with antidepressants. Curr Drug Saf. (Review of drug induced liver injury due to antidepressants including MAO inhibitors).
(2013). Drugs for psychiatric disorders. Treat Guidel Med Lett. (Review of drugs used for depression mentions that MAO inhibitors "remain valuable alternatives for patients with moderate to severe treatment resistant depression;” discussion of side effects does not mention hepatotoxicity).
Shulman KI, Herrmann N, Walker SE. (2013). Current place of monoamine oxidase inhibitors in the treatment of depression. CNS Drugs. (History of the discovery that hydrazine-based drugs had potent antidepressant activity and subsequent development of nonspecific and specific, irreversible and reversible MAO A and B inhibitors which have similar antidepressant effects but different relative risks for complications such as hypertension from dietary intake of tyramine [as in aged cheese] and serotonin syndrome from use of a second serotonin-enhancing agent, such as a tricyclic, SSRI or SNRI as well as some opiates).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, only one of which was attributed to an antidepressant [amitriptyline] and none to a MAO inhibitor, SSRI or SNRI).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al. (2015). United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to antidepressants including 9 due to SNRIs [7 to duloxetine, 1 each to nefazodone and trazodone], 5 to bupropion, 5 to SSRIs [3 to escitalopram, and 1 each to fluoxetine and sertraline], 1 to tricyclics [imipramine] and none to MAO inhibitors).
Malik A, Junglee N. (2015). A case of the serotonin syndrome secondary to phenelzine monotherapy at therapeutic dosing. Case Rep Med. (27 year old woman developed weakness 2 weeks after starting phenelzine [15 mg three times daily] with episodic fever, tachycardia, and clonus, resolving within days of stopping and no other serotonin enhancing agent being taken).
Mateo-Carrasco H, Muñoz-Aguilera EM, García-Torrecillas JM, Abu Al-Robb H. (2015). Serotonin syndrome probably triggered by a morphine-phenelzine interaction. Pharmacotherapy. (57 year old woman on long term phenelzine developed hallucinations and clonus within a few days of starting morphine sulfate [10 mg every 4 to 6 hours], resolving within 48 hours of stopping both and later able to restart phenelzine without recurrence).
Voican CS, Martin S, Verstuyft C, Corruble E, Perlemuter G, Colle R. (2016). Liver function test abnormalities in depressed patients treated with antidepressants: a real-world systematic observational study in psychiatric settings. PLoS One. (Among 321 psychiatric inpatients, only 116 [36%] had liver tests performed and only 18 during therapy with an antidepressant, 3 of which were suspected to have drug induced liver injury, 1 each with escitalopram, venlafaxine and amitriptyline, all without jaundice and 2 without symptoms, all 3 resolving).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. (2016). Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol. (Among 184,234 psychiatric inpatients from 80 hospitals, 149 cases [0.08%] of drug induced liver injury were reported including 22 of 70,060 [0.03%] receiving SSRIs, 71 of 50,201 [0.14%] patients treated with tricyclics and 3 of 3869 receiving MAO inhibitors [0.08%]).
Gahr M, Zeiss R, Lang D, Connemann BJ, Hiemke C, Schönfeldt-Lecuona C. (2016). Drug-Induced liver injury associated with antidepressive psychopharmacotherapy: an explorative assessment based on quantitative signal detection using different MedDRA terms. J Clin Pharmacol. (Using data on adverse drug reaction reports from the Uppsala Monitoring Center of WHO, there were higher relative hepatotoxicity reports for nefazodone, agomelatine, many tricyclics and mirtazapine).
Shao W, Brown T, Ayub S. (2017). Phenelzine withdrawal-associated psychosis and mania. J Clin Psychopharmacol. (49 year old physician developed acute psychosis shortly after discontinuing the self-prescribed combination of N,N-dimethyltryptamine [DMT] and phenelzine [used to decrease metabolism of DMT thus increasing its effect] which resolved within 2 weeks, but follow up evaluation was not available).
Chen VC, Lin CF, Hsieh YH, Liang HY, Huang KY, Chiu WC, Lee Y, McIntyre RS, et al. (2017). Hepatocellular carcinoma and antidepressants: a nationwide population-based study. Oncotarget. (Among almost 50,000 cases of hepatocellular carcinoma registered in the Taiwan National Health Insurance Research Database, the rate of antidepressant use was lower than in approximately 250,000 matched controls from the database).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al., DILI-IT Study Group. (2018). Antidepressant-Induced Acute liver injury: a case-control study in an Italian inpatient population. Drug Saf. (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an Italian prospective study between 2010 and 2014, 17 had been exposed to antidepressants the major implicated agents being citalopram [n=4], sertraline [n=3], paroxetine [n=3], tricyclics [n=2], trazodone [n=1], fluoxetine [n=1], and duloxetine [n=1]; no MAO inhibitors listed).
Billioti de Gage S, Collin C, Le-Tri T, Pariente A, Bégaud B, Verdoux H, Dray-Spira R, et al. (2018). Antidepressants and hepatotoxicity: a cohort study among 5 million individuals registered in the French National Health Insurance Database. CNS Drugs. (Among 5 million persons identified in a national French health insurance database who started an antidepressant between 2010 and 2015, 382 developed serious liver injury resulting in hospitalization, rates per 100,0000 persons-years being 19 for SSRIs, 22 venlafaxine, 13 duloxetine, and 33 mirtazapine; no MAO inhibitors discussed).
Pladevall-Vila M, Pottegård A, Schink T, Reutfors J, Morros R, Poblador-Plou B, Timmer A, et al. (2019). Risk of acute liver injury in agomelatine and other antidepressant users in four European countries: a cohort and nested case-control study using automated health data sources. CNS Drugs. (Analysis of data sources from 4 European countries identified 3.2 million persons initiating antidepressant therapy, among whom there was no increased risk for acute liver injury for agomelatine compared to citalopram, an SSRI with a low rate of hepatotoxicity; MAO inhibitors not discussed).
(2020). Drugs for depression. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for depression, mentions that tricyclics and MAO inhibitors remain valuable alternatives for treatment of moderate-to-severe depression, despite concerns about their safety; hepatotoxicity is mentioned only for nefazodone [now rarely used because of severe hepatotoxicity] and duloxetine [in heavy drinkers]).
Ueberberg B, Frommberger U, Messer T, Zwanzger P, Kuhn J, Anghelescu I, Ackermann K, Assion HJ. (2020). Drug-induced liver injury (DILI) in patients with depression treated with antidepressants: a retrospective multicenter study. Pharmacopsychiatry. (Among 329 psychiatric inpatients with depression seen at 6 psychiatric centers in Germany, 17 [5%] had serum aminotransferase elevations but none had clinically apparent liver injury, most commonly implicated drugs included mirtazapine, agomelatine, citalopram and venlafaxine; MAO inhibitors not mentioned).
Gross ME, Agus DB, Dorff TB, Pinski JK, Quinn DI, Castellanos O, Gilmore P, et al. (2020). Phase 2 trial of monoamine oxidase inhibitor phenelzine in biochemical recurrent prostate cancer. Prostate Cancer Prostatic Dis. (Among 20 patients with recurrent prostate cancer and PSA elevations after prostatectomy treated with phenelzine [30 mg twice daily] for six months, PSA levels decreased in 6 subjects and increased in 6, while another 6 patients discontinued therapy because of toxicity; hypertension in 1 and syncope in 2; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Phenelzine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(phenelzine)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Phenelzine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=phenelzine)